# Causality Assessment Tools

Drug induced liver injury is a diagnosis of exclusion that rests upon ruling out other common causes of liver disease, and knowledge of the pattern of injury associated with the specific drug. Unlike in hepatitis A or B, for instance, there are no specific diagnostic tests that establish causality for drug induced liver injury. The diagnosis can also be very challenging and even experts can disagree on the likelihood of the causality. For these reasons, attempts have been made to standardize causality assessment in drug induced adverse events including hepatotoxicity. These "instruments" generally rely upon careful delineation of the timing of onset of the adverse event in relation to starting the medication (challenge), and the timing of resolution in relation to stopping the medication (dechallenge). The causality is greatly strengthened if there is a recurrence on reexposure (rechallenge). Other helpful features are signs and symptoms of hypersensitivity, know drug allergies, the absence of competing diagnoses, and previous information on the occurrence of a similar adverse event with the medication. These factors are variously captured in the causality instruments and given various weights to achieve a rating score for the likelihood of the medication causing the injury. Commonly used instruments include the Naranjo Probability Scale, which is not specific to liver injury and can be used for any type of adverse drug reaction. In contrast, the Roussel Uclaf Causality Assessment Method (RUCAM) and its modification known as the Maria and Victorino (M & V) System, were developed specifically for drug induced liver injury. All three causality instruments have been used widely and perform reasonably well in comparison to the "gold standard" of expert opinion. These three causality assessment tools are discussed in detail in the links below, and the actual forms are provided in pdf files that can be printed. In addition, guidance is provided on how to fill out the forms. A computerized version of the RUCAM scale is used in the section of LiverTox called "Submit a Case Report." However, subjective features of all of the causality assessment instruments make computerized computations difficult and not as reliable as individual assignment of scores on the forms.

- Maria & Victorino (M & V) System of Causality Assessment
- Adverse Drug Reaction Probability Scale (Naranjo)
- Roussel Uclaf Causality Assessment System (RUCAM)